# Tizanidine

## OVERVIEW

### Introduction

Tizanidine is a commonly used muscle relaxant that has been linked to rare instances of acute liver injury, a few of which have been fatal.

### Background

Tizanidine (tye zan' i deen) is an imidazoline derivative and is a centrally acting muscle relaxant used for therapy of acute muscle spasms and chronic spasticity. The mechanism by which tizanidine causes skeletal muscle relaxation is not well known; it appears to act at the level of spinal cord pain reflexes, most likely through activity as a central alpha-adrenergic agonist which results in an decrease in activity of motor neurons. Tizanidine was approved for use in the United States in 1996 and currently several million prescriptions are filled yearly. The current indications are limited to short-term management of spasticity. Tizanidine is available in several generic forms as well as under the brand name of Zanaflex in tablets and capsules of 2, 4 or 6 mg. The recommended dose in adults is 2 to 6 mg orally three to four times daily. Common side effects include tiredness, drowsiness, dizziness, muscular weakness, dry mouth and occasionally hypotension.

### Hepatotoxicity

Transient and asymptomatic elevations in serum ALT greater than 3 times the upper limit of normal occur in ~5% of patients taking tizanidine compared to 0.4% of subjects on placebo. Reports of severe hepatotoxicity, acute liver failure and death have been mentioned in review articles on tizanidine, but few case reports have been published. In these reports, the latency to onset of jaundice has ranged from 2 to 14 weeks and the enzyme elevations have been both cholestatic and hepatocellular (Case 1). Immunoallergic and autoimmune features have not been mentioned. Recovery was complete after 1 to 2 months.

Likelihood score: C (Probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of acute hepatic injury from tizanidine is unknown, but is probably idiosyncratic due to hypersensitivity.

### Outcome and Management

The idiosyncratic liver injury due to tizanidine ranges from hepatitis with jaundice to acute liver failure leading to death. Chronic injury and vanishing bile duct syndrome have not been reported after tizanidine therapy. Recurrence on re-exposure has been reported and rechallenge should be avoided. No cross reactivity with other muscle relaxants has been identified.

Drug Class: Muscle Relaxants

## CASE REPORT

### Case 1. Acute hepatocellular injury with jaundice after tizanidine therapy.

[Modified from: de Graaf EM, Oosterveld M, Tjabbes T, Stricker BH. A case of tizanidine-induced hepatic injury. J Hepatol 1996; 25: 772-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/8938559)]

A 55 year old woman with multiple sclerosis and lower limb muscle spasms developed jaundice 4 months after starting tizanidine therapy. The jaundice had been preceded by a 2 week period of progressive fatigue, nausea and poor appetite. She denied a history of liver disease or exposure to hepatitis and did not drink alcohol. Her other medications included baclofen, chlormezanone, diazepam, flurazepam, dexchlorpheniramine and diclofenac, all of which she had been taking chronically. On examination, she was deeply jaundiced and somnolent. She had no signs of chronic liver disease and did not have rash or fever. Laboratory testing showed a total bilirubin of 26.5 mg/dL and marked elevations in serum aminotransferase levels with minimal increase in alkaline phosphatase (Table). Tests for hepatitis A, B and C were negative as were autoantibodies (smooth muscle antibody was marginally positive). An abdominal ultrasound showed no evidence of biliary obstruction. Tizanidine had been discontinued 2 weeks before admission, but she worsened during the next several weeks, but then began a spontaneous recovery which was complete 2 months later. Several months later, the patient was inadvertently rechallenged with a single 4 mg dose of tizanidine and within 6 days the ALT levels had increased from 14 to 155 U/L. Tizanidine was discontinued again, and one week later serum ALT levels had returned to normal.

#### Key Points

Medication: | Tizanidine 36 mg daily
Pattern: | Hepatocellular (R=15)
Severity: | 4+ (jaundice, hospitalization, mild hepatic failure)
Latency: | 14 weeks to onset of symptoms
Recovery: | Complete recovery 2 months after stopping
Other medications: | Baclofen, diclofenac, chlormezanone, diazepam, flurazepam, dexchlorpheniramine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
0 | | Tizanidine started
2 days | 0 | Normal | Normal | Normal
16 days | 0 | Tizanidine stopped
18 days | 2 days | 830 | 187 | 26.5 | Admission. INR=1.6
22 days | 8 days | 270 | | 36.0
24 days | 10 days | 60 | | 30.0
26 days | 12 days | 30 | | 4.0
30 days | 16 days | 14 | | 1.0 | Single dose of tizanidine
31 (1)** days | 17 (1) days | 155 | | 1.0
32 (2) days | 18 (2) days | 30 | | 1.0
Normal Values | | <30 | <100 | <1.2

* Bilirubin levels converted from μmol/L. Some values were estimated from Figure 1.

** Values in parentheses are the number of days after rechallenge

#### Comment

The onset of hepatic injury after 4 months of therapy, the improvement with stopping treatment, and the accelerated recurrence of hepatic injury with restarting tizanidine make it highly likely that the hepatitis was due to tizanidine induced liver injury. The pattern of injury was distinctly hepatocellular. Diclofenac can also cause similar hepatocellular injury, but the other features and particularly the rechallenge argue in support of tinazidine as the cause. The rapidity of recurrence on reexposure suggests that the hepatic injury was due to hypersensitivity. The muscle relaxants are a diverse group of medications and share little in structure or mechanisms of action, so that cross sensitivity to hepatic injury should not be a problem. This patient was restarted on baclofen and a benzodiazepam without complication.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tizanidine – Generic, Zanaflex®

DRUG CLASS

Autonomic Agents: Muscle Relaxants, Central

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=tizanidine)

Product Labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Tizanidine | 51322-75-9 | C9-H8-Cl-N5-S | Tizanidine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: January 30, 2017

Zimmerman HJ. Muscle spasmolytics. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 544-45. (Expert review of hepatotoxicity published in 1999; discusses dantrolene, chlorzoxazone and baclofen, but not tizanidine).
Hibbs RE, Zambon AC. Agents acting at the neuromuscular junction and autonomic ganglia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p. 255-76. (Textbook of pharmacology and therapeutics).
Fryda-Kaurimsky Z, Müller-Fassbender H. Tizanidine (DS 103-282) in the treatment of acute paravertebral muscle spasm: a controlled trial comparing tizanidine and diazepam. J Int Med Res 1981; 9: 501-5. (Among 10 patients treated with tizanidine, no mention of hepatic adverse effects). 6459256
Smolenski C, Muff S, Smolenski-Kautz S. A double-blind comparative trial of new muscle relaxant, tizanidine (DS 103-282), and baclofen in the treatment of chronic spasticity in multiple sclerosis. Curr Med Res Opin 1981; 7: 374-83. (Among 21 patients treated with tizanidine or baclofen for 6 weeks, no mention of hepatotoxicity of either drug). 7016449
Newman PM, Nogues M, Newman PK, Weightman D, Hudgson P. Tizanidine in the treatment of spasticity. Eur J Clin Pharmacol 1982; 23: 31-5. (Among 36 patients treated with tizanidine for chronic spasticity, 3 developed mild ALT elevations, but levels were below 50 U/L and resolved spontaneously). 6751834
Lapierre Y, Bouchard S, Tansey C, Gendron D, Barkas WJ, Francis GS. Treatment of spasticity with tizanidine in multiple sclerosis. Can J Neurol Sci 1987; 14 (3 Suppl): 513-7. (Among 33 patients treated with tizanidine, 2 developed significant ALT and AST elevations, both resolved after stopping drug). 3676923
Stien R, Nordal HJ, Oftedal SI, Slettebø M. The treatment of spasticity in multiple sclerosis: a double-blind clinical trial of a new anti-spastic drug tizanidine compared with baclofen. Acta Neurol Scand 1987; 75: 190-4. (Among 40 patients given either tizanidine or baclofen for 6 weeks, no changes observed in laboratory tests of liver function or mention made of hepatotoxicity of either drug). 3554879
Bass B, Weinshenker B, Rice GP, Noseworthy JH, Cameron MGP, Hader W, Bouchard S, et al. Tizanidine versus baclofen in the treatment of spasticity in patients with multiple sclerosis. Can J Neurol Sci 1988; 15: 15-9. (Double blind cross over study of tizanidine vs baclofen for 5 weeks each; routine laboratory monitoring found no alterations in biochemical test results with either agent). 3345456
Berry H, Hutchinson DR. A multicentre placebo-controlled study in general practice to evaluate the efficacy and safety of tizanidine in acute low-back pain. J Int Med Res 1988; 16: 75-82. (Among 112 patients in a placebo controlled trial [59 treated with tizanidine], no hepatic adverse events reported). 2967780
Berry H, Hutchinson DR. Tizanidine and ibuprofen in acute low-back pain: results of a double-blind multicentre study in general practice. J Int Med Res 1988; 16: 83-91. (Placebo controlled trial of tizanidine with ibuprofen for 7 days in patients with low back pain; no hepatic adverse events reported in 51 tizanidine treated patients). 2967781
Bes A, Eyssette M, Pierrot-Deseilligny E, Rohmer F, Warter JM. A multi-centre, double-blind trial of tizanidine, a new antispastic agent, in spasticity associated with hemiplegia. Curr Med Res Opin 1988; 10: 709-18. (Randomized controlled trial of tizanidine versus diazepam for 8 weeks in 105 patients with spasticity; there were no changes in “biochemical parameters” during the study). 3286129
Eyssette M, Rohmer F, Serratrice G, Warter JM, Boisson D. Multi-centre, double-blind trial of a novel antispastic agent, tizanidine, in spasticity associated with multiple sclerosis. Curr Med Res Opin 1988; 10: 699-708. (Among 100 patients in a randomized controlled trial of baclofen vs tizanidine for spasticity, 1 on tizanidine developed bilirubin and ALT elevations and skin rash, but ALT levels had been elevated before therapy). 3286128
Hoogstraten MC, van der Ploeg RJ, vd Burg W, Vreeling A, van Marle S, Minderhoud JM. Tizanidine versus baclofen in the treatment of spasticity in multiple sclerosis patients. Acta Neurol Scand 1988; 77: 224-30. (Among 16 patients treated with tizanidine and baclofen in a cross over study, muscle weakness was more common with baclofen; no mention of laboratory tests or hepatotoxicity). 3376747
Lang AE, Riley DE. Tizanidine in cranial dystonia. Clin Neuropharmacol 1992; 15: 142-7. (Among 10 patients treated with tizanidine, one had elevated ALT levels before therapy which remained elevated during and after treatment). 1591739
Wallace JD. Summary of combined clinical analysis of controlled clinical trials with tizanidine. Neurology 1994; 44 (Suppl 9): S60-8; discussion S68-9. (Review of 525 patients treated with tizanidine in 3 controlled trials, 2 patients developed significant liver enzyme elevations; but many had "slight" abnormalities [all <10 times ULN], which resolved with reduction of dosage or discontinuation). 7970013
Rustemovic N, Huic M, Opacic M. Tinanidine-induced acute toxic hepatitis: case report. Pharmaca 1994; 32: 457-61. Not in PubMed (Report of toxic hepatitis cited in Henney [2009]).
de Graaf EM, Oosterveld M, Tjabbes T, Stricker BH. A case of tizanidine-induced hepatic injury. J Hepatol 1996; 25: 772-3. (55 year old woman developed jaundice 14 weeks after starting tizanidine [bilirubin 26.5 mg/dL, ALT 830 U/L, Alk P 187 U/L], resovling within 6 weeks; recurrence of ALT elevations after reexposure to a single tablet: Case 1). 8938559
Groves L, Shellenberger MK, Davis CS. Tizanidine treatment of spasticity: a meta-analysis of controlled, double-blind, comparative studies with baclofen and diazepam. Adv Ther 1998; 15: 241-51. (In a metaanalysis of 10 trials in 270 patients comparing baclofen and tizanidine, both agents were said to be generally well tolerated; but, no mention was made of ALT abnormalities or hepatotoxicity). 10186943
Afonso Pérez E, Pego Reigosa R, Lancho Seco A, Brañas Fernández F. [Tizanidine-induced toxic hepatitis] Med Clin(Barc) 1999; 112: 478-9. Spanish. (73 year old man received tizanidine for spasticity after ischemic stroke, developed malaise and jaundice 17 days later [bilirubin 7.2 mg/dL, ALT 616 U/L, Alk P 2810 U/L], resolving within 3 weeks of stopping). 10320966
Saper JR, Winner PK, Lake AE 3rd. An open-label dose-titration study of the efficacy and tolerability of tizanidine hydrochloride tablets in the prophylaxis of chronic daily headache. Headache 2001; 41: 357-68. (Among 39 patients with frequent headaches treated for 12 weeks with tizanidine, one developed elevated ALT levels [320 U/L] without jaundice or symptoms, which resolved on stopping the drug). 11318882
Chou R, Peterson K, Helfand M. Comparative efficacy and safety of skeletal muscle relaxants for spasticity and musculoskeletal conditions: a systematic review. J Pain Symptom Manage 2004; 28: 140-75. (Thorough review of the pharmacology, efficacy and side effects of the muscle relaxants). 15276195
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to tizanidine or other muscle relaxants). 15390328
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, one was attributed to chlorzoxazone, but none to tizanidine or other muscle relaxants). 18955056
Henney HR 3rd, Chez M. Pediatric safety of tizanidine: clinical adverse event database and retrospective chart assessment. Paediatr Drugs 2009;11:397-406. (Summary of tizanidine adverse events in children from off-label use with major focus on somnolence, enuresis and anxiety; ALT elevations mentioned, but they were mild and largely attributed to concurrent anticonvulsant therapy). 19877725
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/20949552) (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to tizanidine or other muscle relaxants).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver iInjury in the General population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to tizanidine or other muscle relaxants). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; one case was attributed to verapamil, but none were linked to amlodipine or other calcium channel blockers). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.7%] were attributed to muscle relaxants, including one to trizanidine: 51 year old man developed jaundice 5 weeks after starting tizanidine [bilirubin peak 4.8 mg/dL, ALT 2387 U/L, Alk P 150 U/L, ANA 1:160] and recovered within 2 months of stopping). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Tizanidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tizanidine/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/12/01%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tizanidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tizanidine)